# Pirfenidone

## OVERVIEW

### Introduction

Pirfenidone is an orally available pyridinone derivative that inhibits collagen formation and is used to treat idiopathic pulmonary fibrosis. Elevations in serum enzyme levels during pirfenidone therapy are not uncommon, but it has yet to be implicated in cases of clinically apparent liver injury with jaundice.

### Background

Pirfenidone (pir fen' i done) is an orally available, antiinflammatory and antifibrotic agent that is used to treat idiopathic pulmonary fibrosis. It is a small molecular weight phenyl substituted pyridinone that has antifibrotic activity both in vitro and in vivo. In animal models, pirfenidone decreases fibroblast proliferation and reduces transforming growth factor-beta (TGF-β) synthesis and activation of fibrogenic pathways. In several prospective, placebo controlled trials, pirfenidone was found to reduce the progression of fibrosis and worsening of lung function in patients with idiopathic pulmonary fibrosis. Pirfenidone was approved for use in the United States in 2014, but has been available in other countries for much longer. It is available as capsules of 267 mg under the brand name Esbriet. The typical initial dose in adults is one capsule (267 mg) orally three times daily, which can be increased to 3 capsules three times daily based upon tolerance. Side effects are not uncommon, but are generally mild and can include photosensitivity, rash and gastrointestinal upset with nausea, diarrhea, dyspepsia, reflux and abdominal pain.

### Hepatotoxicity

In large randomized controlled trials, serum aminotransferase elevations more than 3 times the upper limit of normal (ULN) occurred in 4% of pirfenidone- compared to less than 1% of placebo-treated patients. The elevations were generally asymptomatic and short lived, resolving with or without dose modification and requiring drug discontinuation in approximately 1% of patients. Despite the frequency of serum enzyme elevations during therapy, clinically apparent liver injury was not reported in preregistration studies. Nevertheless, since the general availability of pirfenidone in the United States and during years of clinical use elsewhere, there have been isolated case reports of clinically apparent liver injury due to pirfenidone, some of which were severe and even fatal. The latency to onset ranged from one month to one year and the injury was usually hepatocellular or mixed. Immunoallergic features were not common.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which pirfenidone might cause liver injury is not known. It is metabolized in the liver largely via the cytochrome P450 system, predominantly CYP 1A2, and liver injury may be due to production of a toxic or immunogenic metabolite. Pirfenidone is also susceptible to drug-drug interactions with strong inducers or inhibitors of CYP 1A2 (such as fluvoxamine).

### Outcome and Management

While chronic therapy with pirfenidone can be associated with mild-to-moderate serum aminotransferase elevations, it has only rarely been linked to cases of clinically apparent liver injury. Nevertheless, monitoring of serum aminotransferase levels monthly during the first 6 months and every 3 months thereafter is recommended. Patients who develop aminotransferase elevations on therapy should be monitored more carefully, and pirfenidone should be permanently discontinued if jaundice or symptoms of liver injury arise or if serum ALT or AST levels rise above 5 times the ULN.

Drug Class: Pulmonary Fibrosis Agents

Other Drugs in the Class: Nintedanib

## CASE REPORT

### Case 1. Fatal, acute liver injury attributed to pirfenidone.(1)

An 77 year old man with Parkinson disease and idiopathic pulmonary fibrosis developed anorexia and nausea within 2 to 3 weeks of starting pirfenidone (200 mg three times daily), which was followed in the next 1 to 2 weeks by dark urine, jaundice and altered sensorium. He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. He had been diagnosed with Parkinson disease 5 years previously and had been on a stable dose of levodopa/carbidopa for years. He denied taking other medications, over-the-counter drugs or herbal products and had no history of drug allergy. His liver test results had been normal in the past. On presentation, he was jaundiced, tachypneic, hypotensive and mildly encephalopathic. Laboratory testing showed total bilirubin of 12.8 mg/dL (direct 7.8), ALT 526 U/L, AST 1260 U/L, Alk P 434 U/L and LDH 687 U/L [R= 4.0]. The INR was 2.1 and serum ammonia 330 µmol/L. He had elevations in serum creatinine [2.1 mg/dL] and blood lactate [6.1 mmol/L] with severe acidosis [pH 7.04]. He was admitted to the intensive care unit and treated with N-acetyl cysteine. Tests for acute hepatitis A, B, C and E were negative as were markers for cytomegalovirus, Epstein Barr virus and herpes virus infection. Routine autoantibodies were undetectable and immunoglobulin levels were normal. Imaging of the liver showed no evidence of biliary obstruction. He rapidly developed multiorgan failure and died within 4 days of admission. Autopsy showed confluent and bridging necrosis, collapse and few surviving, swollen and vacuolated hepatocytes, no fibrosis and mild portal inflammation suggestive of acute liver failure due to drug induced liver injury.

#### Key Points

Medication: | Pirfenidone (600 mg daily)
Pattern: | Hepatocellular (R=9.6)
Severity: | 5+ (jaundice, hospitalization, death)
Latency: | 3-4 weeks
Recovery: | None
Other medications: | Levodopa/carbodopa for several years

#### Comment

This was a dramatic example of acute liver failure arising in an elderly man who had recently started pirfenidone. The precipitous onset and course suggests that shock and hypoxia may have contributed to the severity of the injury and fatal outcome. While instances of serum aminotransferase elevations without jaundice have been reported with pirfenidone therapy, there have been no instances of moderate injury with jaundice and a self-limited course reported in the literature. Nevertheless, this case is somewhat convincing. No other cause of jaundice was found despite extensive testing and the autopsy was consistent with drug induced liver injury. The product label for pirfenidone states that cases of hepatitis, jaundice and fatal hepatotoxicity during pirfenidone therapy have been reported to the sponsor. Furthermore, it recommends regular monitoring of liver tests before and monthly for the first 6 months of treatment. In this case, the liver injury arose during the first month of treatment and would not have been prevented by such screening. Furthermore, the capsule size used was lower than the standard (200 mg rather than 267 mg amounts) and there was no dose escalation to 3 capsules 3 times daily as is recommended in treatment of patients with idiopathic pulmonary fibrosis.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pirfenidone – Esbriet®

DRUG CLASS

Pulmonary Fibrosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pirfenidone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pirfenidone | 53179-13-8 | C12-H11-N-O

## CITED REFERENCE

1 Verma N, Kumar P, Mitra S, Taneja S, Dhooria S, Das A, Duseja A, et al. Drug idiosyncrasy due to pirfenidone presenting as acute liver failure: Case report and mini-review of the literature. Hepatol Commun 2017; 2: 142-7.29404521

## ANNOTATED BIBLIOGRAPHY

References updated: 25 April 2025

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013; does not discuss pirfenidone).
Angulo P, MacCarty RL, Sylvestre PB, Jorgensen RA, Wiesner RH, LaRusso NA, Lindor KD. Pirfenidone in the treatment of primary sclerosing cholangitis. Dig Dis Sci 2002; 47: 157-61. (Among 24 patients with primary sclerosing cholangitis treated with pirfenidone [2400 mg daily] for 1 year, AST and Alk P levels, histology and cholangiography findings did not change significantly, while adverse events were frequent and 1 patient had worsening of liver disease after 6 months of therapy leading to referral for liver transplantation). 11837718
Gahl WA, Brantly M, Troendle J, Avila NA, Padua A, Montalvo C, Cardona H, et al. Effect of pirfenidone on the pulmonary fibrosis of Hermansky-Pudlak syndrome. Mol Genet Metab 2002; 76: 234-42. (Among 21 adults with Hermansky-Pudlak syndrome and progressive pulmonary fibrosis treated with pirfenidone or placebo for up to 3 years, serum ALT levels did not change and there were no serious hepatic adverse events). 12126938
Azuma A, Nukiwa T, Tsuboi E, Suga M, Abe S, Nakata K, Taguchi Y, et al. Double-blind, placebo-controlled trial of pirfenidone in patients with idiopathic pulmonary fibrosis. Am J Respir Crit Care Med 2005; 171: 1040-7. (Among 107 patients with idiopathic pulmonary fibrosis treated with pirfenidone or placebo for 6 months, one patient discontinued therapy because of abnormal liver tests and one developed a liver cancer, both of whom were on pirfenidone). 15665326
Armendáriz-Borunda J, Islas-Carbajal MC, Meza-García E, Rincón AR, Lucano S, Sandoval AS, Salazar A, et al. A pilot study in patients with established advanced liver fibrosis using pirfenidone. Gut 2006; 55: 1663-5. (Among 15 patients with chronic hepatitis C treated with pirfenidone for 12 months [1200 mg daily], ALT levels declined and paired liver biopsies showed improvements in fibrosis scores in 5 and stable scores in 10 patients). 17047115
Rockey DC. Current and future anti-fibrotic therapies for chronic liver disease. Clin Liver Dis 2008; 12: 939-62. (Review of the pathogenesis and cellular pathways of fibrosis in patients with chronic liver disease, and the status of antifibrotic agents, none of which have been shown to be effective in treating or preventing hepatic fibrosis). 18984475
Taniguchi H, Ebina M, Kondoh Y, Ogura T, Azuma A, Suga M, Taguchi Y, et al.; Pirfenidone Clinical Study Group in Japan. Pirfenidone in idiopathic pulmonary fibrosis. Eur Respir J 2010; 35: 821-9. (Among 275 patients with idiopathic pulmonary fibrosis treated with pirfenidone [1200 or 1800 mg daily] or placebo for 12 months, the decline in lung vital capacity was less with pirfenidone [-0.08 and -0.09] than placebo [-0.16]; photosensitivity occurred in 51-52% on pirfenidone and GGT elevations in 22-23%; no mention of clinically apparent liver injury). 19996196
O'Brien K, Troendle J, Gochuico BR, Markello TC, Salas J, Cardona H, Yao J, et al. Pirfenidone for the treatment of Hermansky-Pudlak syndrome pulmonary fibrosis. Mol Genet Metab 2011; 103: 128-34. (Among 35 patients with Hermansky-Pudlak syndrome and pulmonary fibrosis who were treated with pirfenidone [n=23] or placebo [n-12] for 1-3 years, mean serum ALT levels did not change and "there was no evidence of ... hepatic toxicity"). 21420888
Noble PW, Albera C, Bradford WZ, Costabel U, Glassberg MK, Kardatzke D, King TE Jr, et al.; CAPACITY Study Group. Pirfenidone in patients with idiopathic pulmonary fibrosis (CAPACITY): two randomised trials. Lancet 2011; 377(9779): 1760-9. (Among 779 patients with pulmonary fibrosis treated in two studies with pirfenidone [1197 or 2403 mg daily] or placebo, side effects included nausea [36%], dyspepsia [19%], anorexia [11%], photosensitivity [12%], rash [32%] and ALT elevations above 3 times ULN [4% vs <1% in controls]). 21571362
Two new drugs for idiopathic pulmonary fibrosis. Med Lett Drugs Ther 2014; 56: 123-4. (Concise review of the mechanism of action, efficacy and safety of pirfenidone and nintedanib for idiopathic pulmonary fibrosis mentions that both agents can increase hepatic enzyme levels and dose adjustment may be required). 25461229
King TE Jr, Bradford WZ, Castro-Bernardini S, Fagan EA, Glaspole I, Glassberg MK, Gorina E, et al.; ASCEND Study Group. A phase 3 trial of pirfenidone in patients with idiopathic pulmonary fibrosis. N Engl J Med 2014; 370: 2083-92. (Among 555 patients with idiopathic pulmonary fibrosis treated with pirfenidone [2403 mg/day] or placebo for 52 weeks, pirfenidone led to a lower rate of disease progression, but a higher rate of adverse events including ALT elevations above 3 times ULN in 2.9% [vs 0.7% in placebo controls], but all elevations "were reversible and without clinically significant consequences"). 24836312
Valeyre D, Albera C, Bradford WZ, Costabel U, King TE Jr, Leff JA, Noble PW, Sahn SA, et al. Comprehensive assessment of the long-term safety of pirfenidone in patients with idiopathic pulmonary fibrosis. Respirology 2014; 19: 740-7. (Among 789 patients with idiopathic pulmonary fibrosis being monitored for safety for an average of 2.6 years, elevated ALT or AST values [above 3 times ULN] occurred in 2.7% on pirfenidone, but none developed clinically apparent liver injury, although 1% required drug discontinuation for the enzyme elevations). 24836849
Cottin V, Maher T. Long-term clinical and real-world experience with pirfenidone in the treatment of idiopathic pulmonary fibrosis. Eur Respir Rev 2015; 24(135): 58-64. Erratum in Eur Respir Rev 2015; 24(137): 545. Dosage error in article. (Analysis of long term, postmarketing monitoring of pirfenidone therapy of idiopathic pulmonary fibrosis focused on the frequency of common adverse events, including nausea [32%], diarrhea [19%], photosensitivity [9%] and rash [26%]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to pirfenidone or other agents for pulmonary fibrosis). 25754159
Khanna D, Albera C, Fischer A, Khalidi N, Raghu G, Chung L, Chen D, et al. An open-label, phase II study of the safety and tolerability of pirfenidone in patients with scleroderma-associated interstitial lung disease: the LOTUSS Trial. J Rheumatol 2016; 43(9): 1672-9. (Among 63 patients with scleroderma and interstitial lung disease treated with pirfenidone in two dose escalation regimens for a total of 16 weeks, adverse events were common [96.8%] and mostly nausea, headache and fatigue; “minor elevations in liver function tests were sporadic and not considered clinically relevant” and ALT levels remained below 3 times ULN). 27370878
Lancaster L, Morrison L, Auais A, Ding B, Iqbal A, Polman B, Flaherty KR. Safety of pirfenidone in patients with idiopathic pulmonary fibrosis: experience from 92 sites in an open-label US expanded access program. Pulm Ther 2017; 3: 317-25. (Among 1620 patients with idiopathic pulmonary fibrosis treated with pirfenidone in an expanded access program for an average of 23 weeks, adverse events occurred in 65%, which were severe in 3% and life-threatening in 0.2%, the most common adverse events being nausea [23%] and fatigue [20%] with ALT elevations above 5 times ULN in 13 patients [0.8%] usually by week 8, and hepatic enzyme elevations being considered severe in 10 [0.6%]). 32026347
Verma N, Kumar P, Mitra S, Taneja S, Dhooria S, Das A, Duseja A, et al. Drug idiosyncrasy due to pirfenidone presenting as acute liver failure: Case report and mini-review of the literature. Hepatol Commun 2017; 2: 142-7. (77 year old man with Parkinson disease and idiopathic pulmonary fibrosis developed jaundice 3-4 weeks after starting pirfenidone [bilirubin 12.8 mg/dL, ALT 526 U/L, Alk P 434 U/L, INR 2.1], with lactic acidosis and hepatic encephalopathy and progressive multiorgan failure dying 4 days after hospital admission: Case 1). 29404521
Benesic A, Jalal K, Gerbes AL. Acute liver failure during pirfenidone treatment triggered by co-medication with esomeprazole. Hepatology 2019; 70: 1869-71. (75 year old man with idiopathic pulmonary fibrosis developed liver test abnormalities a year after starting pirfenidone and 3 days after starting omeprazole for gastroesophageal reflux [bilirubin 6.4 mg/dL, ALT 973U/L, Alk P 379 U/L, INR 1.24], with progressive worsening despite stopping both drugs [bilirubin rising to 23.6 mg/dL], leading to hepatic and multiorgan failure and death 24 days after presentation). 31034631
Liao KM, Chen CY. Risk of potential hepatotoxicity from pirfenidone or nintedanib in patients with idiopathic pulmonary fibrosis: results of a retrospective analysis of a large insurance database in Taiwan. Front Pharmacol. 2024;15:1309712. (Analysis of the Taiwan National Health Insurance Research Database between 2017 and 2020 identified the incidence of drug induced liver injury among patients with pulmonary fibrosis treated with either pirfenidone [3 events in 321 patients: 0.9%] vs nintedanib [39 of 1359: 2.8%]; no clinical details provided). 38384288
Fortunati F, Froidure A, Baldin P, Horsmans Y, Lanthier N, Dahlqvist G, Delire B. Pirfenidone-induced liver injury, a case report of a rare idiosyncratic reaction. Ther Adv Drug Saf. 2024;15:20420986241270866. (70 year old woman developed fatigue, pruritus, and jaundice 6 months after starting pirfenidone [801 mg thrice daily] for idiopathic pulmonary fibrosis [bilirubin 8.9 mg/dL, ALT 966 U/L, Alk P 192 U/L, INR 1.32], after the drug was stopped, all abnormalities resolved over the next 2 months). 39286238

## OTHER REFERENCE LINKS

1. Recent References on Pirfenidone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pirfenidone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Pirfenidone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pirfenidone)